# Jin Bu Huan

## OVERVIEW

### Introduction

Jin Bu Huan is a Chinese herb used for centuries as a mild sedative and analgesic, recently marketed for insomnia, arthritic and orthopedic pain and gastrointestinal complaints. Jin Bu Huan products have been implicated in more than a dozen cases of idiosyncratic, clinically apparent, acute liver injury but the hepatotoxicity was likely due to a contaminant rather than Jin Bu Huan itself.

### Background

Jin Bu Huan is a popular and widely used Chinese herbal medication which can contain several unrelated herbal species including Lycopodium serratum, Panax, Pseudo ginseng, Polygala chinensis and two species of Stephania. Jin Bu Huan has been used for centuries in China for multiple purposes including as a sedative, analgesic and decongestant for conditions ranging from asthma and bronchitis to night blindness, delirium, epilepsy, vertigo, fever and inflammation. The bases for the sedative, analgesic and antiinflammatory effects of Jin Bu Huan are not clear. Tetrahydropalmatine has been identified as a major constituent in some preparations of Jin Bu Huan. This compound has sedating effects possibly due to dopamine receptor or calcium channel antagonism.

### Hepatotoxicity

More than a dozen cases of hepatotoxicity attributable to products sold as Jin Bu Huan have been reported, with onset of liver test abnormalities or jaundice within 2 to 24 weeks of starting the herbal supplement. The enzyme pattern was typically hepatocellular, and the clinical syndrome resembled acute viral hepatitis with marked serum aminotransferase abnormalities and minimal increases in alkaline phosphatase levels. Fever, headache and dizziness were also common. Eosinophilia and rash have been reported but were not prominent, nor were autoantibodies frequent. In several instances, continuation of Jin Bu Huan led to chronic aminotransferase elevations and a syndrome that resembles chronic hepatitis. Recovery was usually within 1 to 2 months of stopping. Recurrence of hepatic injury with restarting Jin Bu Huan occurred and resulted in more severe injury. The reported cases were associated with a specific commercial preparation of Jin Bu Huan (Anodyne) and it is unclear whether the injury was due to the traditional herbal combination or to a contamination or mislabeling of the subsequently withdrawn commercial product. After withdrawal of the implicated product, there have been no further reports of liver injury related to Jin Bu Huan, which remains a popular and widely available Chinese herbal remedy.

Likelihood score: cannot be assessed.

### Mechanism of Injury

The mechanism of hepatotoxicity of Jin Bu Huan is not known, but some extracts are usually rich in levo-tetrahydropalmatine, which may have hepatotoxic potential. On the other hand, the majority of cases of hepatotoxicity from Jin Bu Huan have had features of an idiosyncratic reaction and may have been due to an adulterant or contaminant.

### Outcome and Management

The severity of hepatotoxicity from Jin Bu Huan ranges from serum enzyme elevations without symptoms to acute hepatitis with marked jaundice. The injury is usually self-limited and rapidly reversible with stopping the herbal. Rechallenge leads to recurrence of injury and should be avoided. There is no evidence that there is cross sensitivity to hepatic injury between Jin Bu Huan and other Traditional Chinese medicines.

Drug Class: Herbal and Dietary Supplements, Chinese and Other Asian Herbal Medicines

## CASE REPORT

### Case 1. Chronic hepatitis due to Jin Bu Huan.

[Modified from: Picciotto A, Campo N, Brizzolara R, Giusto R, Guido G, Sinelli N, Lapertosa G, Celle G. Chronic hepatitis induced by jin bu huan. J Hepatol 1998; 28: 165-7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/9537855)]

A 49 year old man was found to have elevations in serum aminotransferase levels two months after starting Jin Bu Huan Anodyne tablets. He did not inform his physicians he was taking this “natural” sedative and analgesic and continued it despite the liver test abnormalities. He was asymptomatic of liver disease and had no other major illnesses. His medical history included inguinal hernia repair, appendectomy and kidney stones. He was not taking any conventional medications, denied alcohol abuse and had no previous history of liver disease or risk factors for viral hepatitis. His serum aminotransferase levels were known to have been normal in the past (Table). Physical examination was unrevealing. Laboratory tests showed serum ALT 274 U/L, AST 154 U/L, alkaline phosphatase 249 U/L (normal 96-279 U/L), GGT 110 U/L, and bilirubin 0.8 mg/dL. Tests for hepatitis A, B and C were negative as were autoantibodies, ceruloplasmin and alpha-1-antitrypsin levels, ferritin and iron saturation. His serum ALT and AST remained elevated, and 10 months after initial presentation he underwent liver biopsy which showed chronic hepatitis with moderate inflammation and early bridging fibrosis. At this point, he admitted to use of Jin Bu Huan which he had started approximately two months before his liver tests were found to be abnormal. Within 1 month of stopping the herbal, his serum ALT and AST fell into the normal range and remained normal in follow up.

#### Key Points

Medication: | Jin Bu Huan Anodyne tablets
Pattern: | Hepatocellular (R=6.8)
Severity: | 1+ (serum enzyme elevations without symptoms or jaundice)
Latency: | 8 weeks
Recovery: | 4 weeks
Other medications: | None

#### Laboratory Values

Months After Starting | Months After Stopping | ALT (U/L)* | AST (U/L)* | Bilirubin (mg/dL) | Other
0 | Pre | 25 | 20 | | Jin Bu Huan started
2 | | 115 | 60
3 | | 130 | 70
4 | | 185 | 90
5 | | 274 | 154 | .0.8
6 | | 260 | 145
7 | | 160 | 100
8 | | 280 | 210
10 | | 160 | 200 | | Liver biopsy
11 | 0 | 100 | 100 | Normal | Jin Bu Huan stopped
12 | 1 | 38 | 36
14 | 3 | 25 | 25
18 | 5 | 30 | 22
Normal Values | | <40 | <40 | <1.2

* Values estimated from Figure 3.

#### Comment

The case history is somewhat typical of herbal induced liver injury, in that the patient did not inform his physicians that he was taking a Chinese herb when he first presented, believing that it was a natural product and unlikely to be harmful or medically important. Even when asked directly, patients may deny taking herbal medications, often because of the perception that Western physicians are hostile to the use of “natural” supplements and would be critical of their use. The clinical presentation resembled chronic hepatitis, being marked by serum aminotransferase elevations without jaundice or alkaline phosphatase abnormalities and a paucity of symptoms. The chronic hepatitis phenotype was confirmed by liver biopsy which showed changes that resembled chronic viral hepatitis including fibrosis. Importantly, the chronic elevations occurred during long term continuing therapy and resolved rapidly once the herbal was stopped. Many medications that cause an acute hepatitis-like syndrome can also cause a chronic hepatitis if the injury is less acute and severe and the medication is continued long term (minocycline, nitrofurantoin, isoniazid). While the clinical pattern may resemble chronic hepatitis, it is usually not self-sustaining, and resolves when the medication is stopped (although the resolution may be slow or delayed).

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Jin Bu Huan – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Jin Bu Huan | No Information | Herbal mixture | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 26 April 2018

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; hepatotoxicity of Chinese herbal products and teas are discussed generally without focus on Jin Bu Huan).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS] mentions that at least 11 cases of acute or chronic hepatitis were linked to a Jin Bu Huan preparation sold in the United States ).
Carlsson C. Herbs and hepatitis. Lancet 1990; 336: 1068. (Analysis of laboratory results from 395 patients found higher ALT levels among 53 patients who were taking herbals [55 U/L] than among those who were not [12 U/L]). 1977040
Eisenberg DM, Kessler RC, Foster C, Norlock FE, Calkins DR, Delbanco TL. Unconventional medicine in the United States. Prevalence, costs, and patterns of use. N Engl J Med 1993; 328: 246-52. (Among 1539 adults interviewed by telephone, 34% used an unconventional therapy during the previous 12 months, including 3% using herbal medicines). 8418405
Horowitz RS, Dart RC, Gomez H, Moore LL, Fulton B. Jin Bu Huan toxicity in children-Colorado. 1993. MMWR 1993; 42: 633-6. (3 children, ages 13, 23 and 30 months, ingested 7, 17 and 60 tablets of Jin Bu Huan, developing lethargy and abnormal breathing within 30-60 minutes, responding rapidly to gastric lavage, activated charcoal and a cathartic, no mention of liver injury). 8774209
Woolf GM, Rojter SE, Villamil FG, Vierling JM. Jin Bu Huan toxicity in adults-Los Angeles, 1993. MMWR 1993; 42: 920-2. (3 women, ages 24, 45 and 66 years, taking Jin Bu Huan for insomnia for 2 to 4 months developed nausea, fatigue, pruritus and jaundice [bilirubin 0.7, 28.0 and 3.4 mg/dL, ALT 786, 1468 and 1308 U/L, Alk P 169, 133, 225 U/L], resolving in 3-9 weeks upon stopping; analysis showed levo-tetrahydropalmatine which is not present in the plant claimed on the label [Polygala chinensis]). 8232178
Perharic L, Shaw D, Colbridge M, House I, Leon C, Murray V. Toxicological problems resulting from exposure to traditional remedies and food supplements. Drug Saf 1994; 11: 284-94. (Retrospective and prospective survey identified 1070 enquires following exposure to herbal products including 4 cases of liver injury from Chinese herbs, psoralea coryliflora, valerian and skullcap). 7848547
Woolf GM, Petrovic LM, Rojter SE, Wainwright S, Villamil FG, Katkov WN, Michieletti P, et al. Acute hepatitis associated with the Chinese herbal product Jin Bu Huan. Ann Intern Med 1994; 10: 729-35. (Seven adults with hepatotoxicity due to Jin Bu Huan; 6 women and 1 man, ages 24 to 66 years, taking Jin Bu Huan for 7 to 52 weeks developed fever, fatigue, nausea, pruritus and jaundice in 3 patients [peak bilirubin 0.4 to 28.0 mg/dL, ALT 192 to 2149 U/L, Alk P 60 to 552 U/L], resolving in 2 to 30 weeks; includes cases from Woolf [1993]). 7944049
Delbano T. Bitter herbs: mainstream, magic and menace. Ann Intern Med 1994; 121: 803-4. (Editorial accompanying Woolf [1994] regarding Jin Bu Huan Anodyne Tablets, which were widely available before their withdrawal because of hepatotoxicity). 7944058
Kaptchuk TJ. Acute hepatitis associated with Jin Bu Huan. Ann Intern Med 1995; 122: 636. (Letter in response to Woolf [1994] arguing that the liver injury was not due to Jin Bu Huan itself, but rather a plant contaminant with highly concentrations of the alkaloid, L-tetrahydropalmatine in the commercial product labeled as Jin Bu Huan). 7741903
Horowitz RS, Feldhaus K, Dart RC, Stermitz FR, Beck JJ. The clinical spectrum of Jin Bu Huan toxicity. Arch Intern Med 1996; 156: 899-903. (6 cases: 3 in children, 2 girls and 1 boy, ages 13, 19 and 30 months, with accidental ingestion of 5, 17 and 60 tablets of Jin Bu Huan presenting within hours with lethargy, ataxia, coma, respiratory depression, but with rapid recovery without sequelae; 3 cases in adults: 50, 55 and 70 year old women, becoming symptomatic after 1, 2 and 24 weeks after starting Jin Bu Huan, 2 with marked ALT elevations but normal bilirubin, 1 with jaundice and ALT 1500 U/L, abnormalities remaining while herb was continued intermittently and falling to normal within 2 months of stopping). 8774209
Huang WF, Wen KC, Hsiao ML. Adulteration by synthetic therapeutic substances of traditional Chinese medicines in Taiwan. J Clin Pharmacol 1997; 37: 344-50. (Prospective analysis of 2609 samples of herbal medications in Taiwan found adulteration in 24%, major adulterants being caffeine, acetaminophen, nonsteroidal antiinflammatory agents, corticosteroids, antihistamines, salicylates, benzodiazepines and barbiturates). 9115061
Picciotto A, Campo N, Brizzolara R, Giusto R, Guido G, Sinelli N, Lapertosa G, Celle G. Chronic hepatitis induced by jin bu huan. J Hepatol 1998; 28: 165-7. (49 year old man found to have raised serum enzymes while taking Jin Bu Huan unbeknownst to his physicians [bilirubin 0.8 mg/dL, ALT 274 U/L, Alk P normal], which persisted for 10 months, biopsy showing chronic hepatitis and bridging fibrosis, liver tests falling to normal upon stopping herbal: Case 1). 9537855
Brent J. Three new herbal hepatotoxic syndromes. J Toxicol Clin Toxicol 1999; 37: 715-9. (Summary of literature on hepatotoxicity of 3 herbals recently described including germander, Jin Bu Huan and chaparral). 10584584
Stedman C. Herbal hepatotoxicity. Semin Liver Dis 2002; 22: 195-206. (Review and description of patterns of liver injury, including discussion of potential risk factors, and herb-drug interactions; Jin Bu Huan is discussed as having been linked to 10 cases of acute and one of chronic hepatitis). 12016550
De Smet PAGM. Herbal remedies. N Engl J Med 2002; 347: 2046-56. (Review of status and difficulties of herbal medications including lack of standardization, federal regulation, contamination, safety, hepatotoxicity and drug-herb interactions; specific discussion of 4 herbs with therapeutic promise: ginkgo, hawthorn, saw palmetto and St. John’s wort). 12490687
Ernst E. Adulteration of Chinese herbal medicines with synthetic drugs: a systematic review. J Intern Med 2002; 252: 107-13. (Systematic review of literature on adulteration of herbals with conventional medications, in 15 case reports and 2 cases series of 21 patients; included NSAIDs, corticosteroids, benzodiazepines, diuretics and antidiabetic medications, in up to 24% of products). 12190885
McRae CA, Agarwal K, Mutimer D, Bassendine MF. Hepatitis associated with Chinese herbs. Eur J Gastroenterol Hepatol 2002; 14: 559-62. (Two patients developed jaundice and severe hepatitis while taking Chinese herbals; discussion mentions Jin Bu Huan as an example of a Chinese herbal with hepatotoxic potential). 11984156
Divinsky M. Case report: jin bu huan – not so benign herbal medicine. Can Fam Physician 2002; 48: 1640-2. (45 year old woman developed jaundice while taking Jin Bu Huan for anxiety [bilirubin 2.4 mg/dL, ALT 1785 U/L, Alk P 115], with resolution in 6 weeks upon stopping herbal given to her by her visiting Chinese father). 12449548
Haller CA, Dyer JE, Ko R, Olson KR. Making a diagnosis of herbal-related toxic hepatitis. West J Med 2002; 176: 39-44. (42 year old woman took 3 herbals including Jin Bu Huan for insomnia and developed jaundice 10 weeks later [bilirubin 1.2 mg/dL, ALT 3386 U/L, Alk P 100 U/L], resolving in 6 weeks; 39 year old woman took several herbs including chaparral and developed jaundice and confusion [bilirubin 42.7 mg/dL, ALT 349 U/L], followed by liver failure and emergency liver transplantation). 11788538
Schiano TD. Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis 2003; 7: 453-73. (Comprehensive review of herbal associated hepatotoxicity, including common patterns of presentation with discussion of Chinese herbal medicines, including Jin Bu Huan, Ma Huang, Shou Wu Pian, and Sho-saiko-to). 12879994
Pittler MH, Ernest E. Systematic review: hepatotoxic events associated with herbal medicinal products. Aliment Pharmacol Ther 2003; 18: 451-71. (Systematic review of published cases of hepatotoxicity due to herbal medications listing 52 case reports or case series, most common agents being celandine [3], chaparral [3], germander [8], Jin Bu Huan [3], kava [1], Ma Huang [3], pennyroyal [1], skullcap [2], Chinese herbs [9], valerian [1]). 12950418
Estes JD, Stolpman D, Olyaei A, Corless CL, Ham JM, Schwartz JM, Orloff SL. High prevalence of potentially hepatotoxic herbal supplement use in patients with fulminant hepatic failure. Arch Surg 2003; 138: 852-8. (Among 20 patients undergoing liver transplantation for acute liver failure during 2001-2, 10 were potentially caused by herbals: 3 Ma Huang, 3 kava, 2 LipoKinetix, 1 chaparral, 1 skullcap and 2 miscellaneous Chinese herbs). 12912743
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications; Jin Bu Huan not mentioned). 15390328
Willett KL, Roth RA, Walker L. Workshop overview: Hepatotoxicity assessment for botanical dietary supplements. Toxicol Sci 2004; 79: 4-9. (Summary of a workshop on the hepatotoxicity of botanicals focusing upon mechanisms of hepatic injury and means of prediction and prevention). 14976355
Myers SP, Cheras PA. The other side of the coin: safety of complementary and alternative medicine. Med J Aust 2004; 181: 222-5. (Discussion of the safety of complementary and alternative medicines). 15310261
Wai CT, Tan BH, Chan CL, Sutedja DS, Lee YM, Khor C, Lim SG. Drug-induced liver injury at an Asian center: a prospective study. Liver Int 2007; 27: 465-74. (Prospective survey of drug induced liver injury presenting over 26 months at a single hospital in Singapore identified 31 cases, ages 18-9 years, 55% male, Chinese traditional medicines being implicated in 17 [55%] and Malay agents in 5 cases [16%], adulterants were found in 9 of 31 tested traditional agents [codeine, corticosteroids, metformin, mercury, nonsteroidal antiinflammatory agents]). 17403186
Seeff LB. Herbal hepatotoxicity. Clin Liver Dis 2007; 11: 577-96. (Review of herbal induced hepatotoxicity, with a review of Chinese herbal medicines such as Chaso, Onshido, Sho-saiko-to, Jin Bu Huan, Ma Huang and Shou Wu Pian). 17723921
Chitturi S, Farrell GC. Hepatotoxic slimming aids and other herbal hepatotoxins. J Gastroenterol Hepatol 2008; 23: 366-73. (Review of hepatotoxicity of herbal medications focusing upon those used for weight loss including nitrosofenfluramine, usnic acid, ephedra, germander, skullcap and green tea). 18318821
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. Liver injury induced by “natural remedies”: an analysis of cases submitted to the Spanish Liver Toxicity Registry. Rev Esp Enferm Dig 2008; 100: 688-95. (Among 521 cases of drug induced liver injury submitted to a Spanish registry, 13 [2%] were due to herbals, including individual cases due to Camellia sinensis [green tea], Cassia angustifolia [senna], kava, valerian, Rhamnus purshianus [cascara], fitosoja [soy], biosoja [soy], Aesculus hippocatanum [horse chestnut], chitosan, Couterea latifloral Copalchi]). 19159172
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications). 18955056
Navarro VJ. Herbal and dietary supplement hepatotoxicity. Semin Liver Dis 2009; 29: 373-82. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS including traditional Chinese herbal medicines and Jin Bu Huan). 19826971
Wang YP, Shi B, Chen YX, Su J, Jiang CF, Xie WF. Drug-induced liver disease: an 8 year study of patients from one gastroenterological department. J Digest Dis 2009; 10: 195-200. (30 patients with drug induced liver disease seen at a single medical university in Shanghai between 2000-2008, of which 12 were attributed to Chinese herbs, but specific agents not discussed, 9 were jaundiced, 6 hepatocellular, 3 cholestatic and 2 mixed). 19659787
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements including 3 publications on Jin Bu Huan [Woolf 1994, Horowitz 1996, Picciotti 1998]). 22928722
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60:1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to a known Jin Bu Huan). 25043597
Teschke R. Traditional Chinese Medicine Induced Liver Injury. J Clin Transl Hepatol 2014; 2: 80-94. (Listing of names of Traditional Chinese Medicines that have been implicated in causing liver injury mentions that Jin Bu Huan hepatotoxicity has been reported from Hong Kong [1 case], the US [11 cases], Canada [1 case] and Italy [1 case], but none since 2002). 26357619
Teschke R, Zhang L, Long H, Schwarzenboeck A, Schmidt-Taenzer W, Genthner A, Wolff A, et al. Traditional Chinese Medicine and herbal hepatotoxicity: a tabular compilation of reported cases. Ann Hepatol 2015; 14: 7-19. (Listing of published cases of hepatoxicity from Traditional Chinese Medicines and analysis of causality using RUCAM identified 4 cases attributed to Jin Bu Huan, 3 scored as probable and 1 possible, and rechallenge results being positive for two cases and negative for two). 25536637
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107 (Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists 4 publications on Jin Bu Huan describing an acute hepatitis possibly due to levo-tetrahydropalmatine or pyrrolizidine alkaloids). 27402097

## OTHER REFERENCE LINKS

1. Recent References on Jin Bu Huan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=jin+bu+huan+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Jin Bu Huan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=jin+bu+huan)